# Mechlorethamine

## OVERVIEW

### Introduction

Mechlorethamine is a nitrogen mustard and antineoplastic agent that has been in clinical use for more than 60 years, given systemically in combination with other antineoplastic agents to treat Hodgkin disease, chronic leukemias, lung cancer and polycythemia vera. Currently, however, it is used largely as a topical gel for therapy of cutaneous T-cell lymphomas and mycosis fungoides. Given parenterally in combination with other antineoplastic agents it was associated with low rates of serum enzyme elevations during therapy, but mechlorethamine has not been implicated specifically in cases of acute, clinically apparent injury.

### Background

Mechlorethamine (mek" lor eth' a meen), also known as chlormethine and mustine, is a nitrogen mustard and was the first alkylating agent developed for use as an antineoplastic agent in man. It remains the most reactive in this class of agents. Because it is irritating to local tissues and causes gastrointestinal intolerance, mechlorethamine is administered intravenously. Modifications of the chemical structure of mechlorethamine has led to similarly effective, but safer and better tolerated forms of alkylating agents, such as cyclophosphamide, ifosfamide, chlorambucil and melphalan. The alkylating agents act by causing modification and cross linking of DNA, thus triggering programmed cell death (apoptosis) and inhibiting DNA, RNA and protein synthesis in rapidly dividing cells. Mechlorethamine was approved for use in the United States in 1949. The major use of mechlorethamine was in a regimen with vincristine, procarbazine and prednisone, commonly referred to as MOPP, used to treat Hodgkin disease and lymphoma. In recent years, mechlorethamine has been replaced by more stable alkylating agents such as cyclophosphamide (COPP). Current listed indications include Hodgkin's disease, lymphosarcoma, chronic leukemias, polycythemia vera, mycosis fungoides and lung cancer. Mechlorethamine was previously available in 10 mg vials generically and under the brand name Mustargen. The recommended dose varied with the indication, patient age and weight. Mechlorethamine is currently available as a topic gel for treatment of cutaneous T-cell lymphomas and mycosis fungoides, but requires special handling. Mechlorethamine shares common side effects with other alkylating agents, which include nausea, vomiting diarrhea, alopecia, pruritus, bone marrow suppression and rash.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels were not uncommon during cycles of cancer chemotherapy regimens that included mechlorethamine, but its role in causing these abnormalities was never entirely clear. The enzyme elevations were usually mild, transient and without symptoms, so that dose modifications of mechlorethamine were rarely needed. Mechlorethamine has not been associated specifically with clinically apparent liver injury. Sinusoidal obstruction syndrome has been reported after MOPP therapy, but largely in patients with other risk factors for this complication, such as total body irradiation or previous courses of antineoplastic therapy. Topical mechlorethamine has not been associated with liver injury, although the possibility of systemic absorption continues to make hepatic adverse events mentioned as a concern. Careful analysis for bone marrow toxicity and plasma concentrations of the drug, however, have failed to demonstrate any evidence for significant absorption with proper use of the cutaneous gel.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The potential mechanism of hepatotoxicity from mechlorethamine is probably similar to that of other alkylating agents, a direct cytotoxic injury which is most specific to rapidly dividing cells, but in high doses can injury other cell types such as sinusoidal lining cells or hepatocytes.

### Outcome and Management

Liver injury including sinusoidal obstruction syndrome are very rare after mechlorethamine therapy. The severity of sinusoidal obstruction syndrome varies considerably, from transient mild symptomatic liver injury to acute liver failure that is rapidly fatal. There is no known specific therapy for sinusoidal obstruction syndrome and management should focus on avoidance of further injury and supportive care. Rechallenge should not be done.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mechlorethamine – Mustargen®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mechlorethamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mechlorethamine | 51-75-2 | C5-H11-Cl2-N | Mechlorethamine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2019

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that mechlorethamine has not been linked to significant liver injury).
DeLeve LD. Alkylating agents. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 551-4. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses alkylating agents but not mechlorethamine specifically; many alkylating agents, particularly if given in high doses with busulfan or irradiation, can cause sinusoidal obstruction syndrome [SOS]).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-1202. (Textbook of pharmacology and therapeutics).
Dameshek W, Weisfuse L, Stein T. Nitrogen mustard therapy in Hodgkin's disease. Blood 1949; 4: 338-79. (Response rates and toxicity of nitrogen mustard in 50 patients with Hodgkin's disease; one patient with preexisting jaundice worsened with therapy, with deepening jaundice, coma and death 9 days later; autopsy showed partial compression of the common bile duct, but also areas of necrosis in the liver). 18116112
Zimmerman HJ, Alpert LK, Howe J. The effect of nitrogen mustard (bis-β-chlorethylamine) on liver function and structure in patients with neoplastic disease. J Lab Clin Med 1952; 40: 387. Not in PubMed (Reported to show no significant worsening of liver function tests in patients with cancer during therapy with mechlorethamine).
De Vita VT, Carbone PP, Owens AH Jr, Gold GL, Krant MJ, Edmonson J. Clinical trials with 1,3-bis(2-chloroethyl)-1-nitrosourea, NSC-409962. Cancer Res 1965; 25: 1876-81. (Preliminary studies of BCNU in 144 patients with malignancies including different dose schedules; AST elevations occurred in 15% after 13-63 days and were self limited in all; liver toxicity may have contributed to the death of one patient). 5858571
Hansen HH, Selawry OS, Muggia FM, Walker MD. Clinical studies with 1-(2-chloroethyl)-3-cyclohexyl-1-nitrosourea (NSC 79037). Cancer Res 1971; 31: 223-7. (Preliminary studies of CCNU in 40 patients with malignancies; there was no consistent hepatic dysfunction; AST elevations occurred in one patient). 4926242
Roth A, Cerlek S, Dominis M, Kolari. K. Liver changes induced by cytostatic drugs in patients with non Hodgkin's lymphomas. Acta Hepatogastroenterol (Stuttg) 1978; 25: 353-9. (Minor elevations in serum enzymes and histological changes of inflammation, fat and hemosiderosis were common among 21 patients with lymphoma treated with MOPP and followed prospectively, but without a consistent pattern and the agent responsible for the changes could not be identified). 726801
Rollins BJ. Hepatic veno-occlusive disease. Am J Med 1986; 8: 297-306. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease, now referred to as sinusoidal obstruction syndrome [SOS]). 3526887
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, SOS developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of hepatic SOS after bone marrow transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation, with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
DeLeve LD, Shulman HM, McDonald GB. Toxic injury to hepatic sinusoids: sinusoidal obstruction syndrome. Semin Liver Dis 2002; 22: 27-41. (Review of clinical features, pathology, etiology, prevention and treatment of sinusoidal obstruction syndrome, a better term for this condition than veno-occlusive disease; first described in association with exposure to phytotoxins [pyrrolizidine alkaloids], the most common cause now is cancer chemotherapy and particularly myeloablative conditioning regimens in preparation for bone marrow transplantation). 11928077
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents). 20373370
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 198 patients with hepatitis of uniknown cause enrolled in a prospective database from 51 Berlin hospitals between 2002 and 2011, none were attributed to mechlorethamine). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to mechlorethamine). 25754159
Liner K, Brown C, McGirt LY. Clinical potential of mechlorethamine gel for the topical treatment of mycosis fungoides-type cutaneous T-cell lymphoma: a review on current efficacy and safety data. Drug Des Devel Ther 2018; 12: 241-254. . (Review of clinical efficacy and safety of mechlorethamine gel mentions that the adverse events are largely dermatologic and local and there is no evidence for its systemic absorption with cutaneous application; no mention of ALT elevations or hepatotoxicity). 29440874

## OTHER REFERENCE LINKS

1. Recent References on Mechlorethamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mechlorethamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Mechlorethamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mechlorethamine)